# Belimumab

## OVERVIEW

### Introduction

Belimumab is a human monoclonal antibody to the soluble B-lymphocyte stimulator (BLsY) which is used in the therapy of systemic lupus erythematous. Belimumab has been linked to an uncommon incidence of transient serum enzyme elevations during therapy, but has yet to be linked to instances of clinically apparent liver injury.

### Background

Belimumab (be lim’ ue mab) is a human monoclonal IgG1 antibody to the B-lymphocyte stimulator (BLyS, B cell activating factor), a growth factor required for B cell activation, survival, maturation into plasma cells and immunoglobulin production. Belimumab binds to soluble BLyS and blocks its binding to B cell receptors, which results in a depletion of activated B cells. This monoclonal antibody has been shown to be effective in reducing disease activity in patients with systemic lupus erythematosus, a disease marked by elevated levels of soluble BLyS, B cell dysregulation and production of pathogenic autoantibodies and immune complexes. Belimumab was approved for use in the United States in 2011 and current indications are for treatment of children (ages 5 years and above) and adult patients with active, autoantibody positive systemic lupus erythematosus (SLE) who are receiving standard therapy. It is also approved as therapy for lupus nephritis. Belimumab is available in two forms under the brand name Benlysta: as a lyophilized powder in 120 and 400 mg single dose vials for intravenous use in children or adults, or as a solution of 200 mg/mL a prefilled autoinjector or singe-dose syringe for subcutaneous use in adults only. For the intravenous formulation, the recommended dose is 10mg/kg every 2 weeks for 3 doses and then every 4 weeks. Premedication with an antihistamine is recommended. For the subcutaneous formulation, the dose is 200 mg once weekly. Adverse effects include infusion reactions, nausea, diarrhea, headache, insomnia, depression, pain in the extremities and low grade fever. Rare, but potentially serious side effects include anaphylactic reactions, serious infections, progressive multifocal leukoencephalopathy (PML), depression and suicide.

### Hepatotoxicity

In publications on the large scale trials of belimumab, elevations in serum aminotransferase levels were uncommon (less than 1%) and no more frequent during belimumab therapy than in placebo treated controls. In the prelicensure studies there were no reports of clinically apparent liver injury attributed to belimumab and, since its approval and more wide scale use, there have been no case reports of liver injury with jaundice linked to belimumab therapy. Reactivation of hepatitis B can occur with use of immunosuppressive monoclonal antibodies such as infliximab and adalimumab, but instances have not been reported with belimumab. However, belimumab does result in a decrease in circulating B cells and immunoglobulin levels and thus might be a cause of reactivation of HBV replication in a susceptible patient. Nevertheless, severe liver injury has not been reported with use of belimumab.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the rare serum enzyme elevations during belimumab therapy is not known. Monoclonal antibodies are generally metabolized to small peptides and amino acids by multiple tissues including the liver and are not intrinsically toxic to hepatocytes. Most clinically significant liver injury induced by monoclonal antibodies is due to induction of autoimmunity or reactivation of hepatitis B.

### Outcome and Management

The serum aminotransferase elevations that have been reported during belimumab therapy were generally transient, mild and asymptomatic and did not require dose modification or delay in therapy. Elevations above 5 times the upper limit of normal should lead to more careful monitoring and suspension of further infusions, at least until levels return to normal or near normal levels. There is no evidence of cross sensitivity to hepatic reactions among the various monoclonal antibodies.

Drug Class: Monoclonal Antibodies; Immunosuppressive Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Belimumab – Benlysta®

DRUG CLASS

Immunosuppressive Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Belimumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Belimumab | 356547-88-1 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 28 December 2020

Abbreviations: PML, progressive multifocal leukoencephalopathy; SLE, systemic lupus erythematosus.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, well before the availability of most antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents does not mention belimumab).
Krensky AM, Azzi JR, Hafler DA. Immunosuppressants and toleragens. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 637-53. (Textbook of pharmacology and therapeutics).
Furie R, Stohl W, Ginzler EM, Becker M, Mishra N, Chatham W, Merrill JT, et al., Belimumab Study Group. (2008). Biologic activity and safety of belimumab, a neutralizing anti-B-lymphocyte stimulator (BLyS) monoclonal antibody: a phase I trial in patients with systemic lupus erythematosus. Arthritis Res Ther. (Among 70 patients with systemic lupus erythematosus [SLE] given 1 to 2 infusions of 4 doses of belimumab or placebo, CD20+ B cells decreased, but indices of disease activity did not change; ALT elevations above 5 times ULN occurred in 1 of 57 belimumab vs none of 13 placebo recipients).
Wallace DJ, Stohl W, Furie RA, Lisse JR, McKay JD, Merrill JT, Petri MA, et al. (2009). A phase II, randomized, double-blind, placebo-controlled, dose-ranging study of belimumab in patients with active systemic lupus erythematosus. Arthritis Rheum. (Among 449 patients with SLE treated with 3 doses of belimumab or placebo for 52 weeks, rates of adverse events were similar except for urticarial [4% vs 0%], no mention of ALT elevations or hepatotoxicity).
Jacobi AM, Huang W, Wang T, Freimuth W, Sanz I, Furie R, Mackay M, et al. (2010). Effect of long-term belimumab treatment on B cells in systemic lupus erythematosus: extension of a phase II, double-blind, placebo-controlled, dose-ranging study. Arthritis Rheum. (Analysis of 17 patients treated with belimumab long term showed decreases in B cells and IgM levels, but not in T cells, IgG or anti-dsDNA levels).
Navarra SV, Guzmán RM, Gallacher AE, Hall S, Levy RA, Jimenez RE, Li EK, et al., BLISS-52 Study Group. (2011). Efficacy and safety of belimumab in patients with active systemic lupus erythematosus: a randomised, placebo-controlled, phase 3 trial. Lancet. (Among 865 patients with SLE treated with two doses of belimumab or placebo for 52 weeks, adverse events were similar in the 3 groups; 3 patients developed anaphylactoid reactions; no mention of ALT elevations or hepatotoxicity).
Sanz I, Yasothan U, Kirkpatrick P. (2011). Belimumab. Nat Rev Drug Discov. (Short review of the development, mechanism of action, efficacy, safety and market value of belimumab).
Furie R, Petri M, Zamani O, Cervera R, Wallace DJ, Tegzová D, Sanchez-Guerrero J, et al., BLISS-76 Study Group. (2011). A phase III, randomized, placebo-controlled study of belimumab, a monoclonal antibody that inhibits B lymphocyte stimulator, in patients with systemic lupus erythematosus. Arthritis Rheum. (Among 819 patients with SLE treated with one of two doses of belimumab or placebo for 52 weeks, a higher proportion of those treated with 10 mg/kg met the response criteria at week 52 [43%] than those treated with 1 mg/kg [41%] or placebo [34%], while rates of most adverse events were similar and ALT elevations were not mentioned; infusions reactions and depression were more frequent with belimumab).
(2011). Belimumab (Benlysta) for systemic lupus erythematosus. Med Lett Drugs Ther. (Concise summary of the mechanism of action, efficacy, safety and costs of belimumab for SLE mentions that belimumab can modestly reduce disease activity, and common side effects are infusion reactions, nausea, diarrhea and fever; no mention of ALT elevations or hepatotoxicity).
Gamble RG, Dellavalle RP. (2012). A randomized controlled trial of belimumab for the treatment of active systemic lupus erythematosus. Arch Dermatol. (Commentary on Navarra [2011]).
Merrill JT, Ginzler EM, Wallace DJ, McKay JD, Lisse JR, Aranow C, Wellborne FR, et al., LBSL02/99 Study Group. (2012). Long-term safety profile of belimumab plus standard therapy in patients with systemic lupus erythematosus. Arthritis Rheum. (Analysis of 1165 patient years of exposure to belimumab during the first 4 years of treatment, states that infusion reactions occurred only during the first year of treatment and that liver test abnormalities [≥grade 3] occurred in <2% of patients and did not increase over time).
Manzi S, Sánchez-Guerrero J, Merrill JT, Furie R, Gladman D, Navarra SV, Ginzler EM, et al., BLISS-52 and BLISS-76 Study Groups. (2012). Effects of belimumab, a B lymphocyte stimulator-specific inhibitor, on disease activity across multiple organ domains in patients with systemic lupus erythematosus: combined results from two phase III trials. Ann Rheum Dis. (Combined analysis of trials reported by Furie [2011] and Navarra [2011]).
Wallace DJ, Navarra S, Petri MA, Gallacher A, Thomas M, Furie R, Levy RA, et al. (2013). BLISS-52 and -76, and LBSL02 Study Groups. Safety profile of belimumab: pooled data from placebo-controlled phase 2 and 3 studies in patients with systemic lupus erythematosus. Lupus. (Pooled data on safety from 3 large trials of belimumab in patients with SLE found similar rates of serious infusion reactions, serious infections and malignancies in placebo vs belimumab treated subjects; no mention of ALT elevations or hepatotoxicity).
Hahn BH. (2013). Belimumab for systemic lupus erythematosus. N Engl J Med. (Review of the clinical features and pathogenesis of SLE and the mechanism of action, efficacy and safety of belimumab in its treatment; in combined studies, responses occurred in 51% of belimumab vs 39% of placebo recipients; adverse events include infusion reactions, depression of serious infections; no mention of ALT elevations of hepatotoxicity).
Stohl W, Merrill JT, McKay JD, Lisse JR, Zhong ZJ, Freimuth WW, Genovese MC. (2013). Efficacy and safety of belimumab in patients with rheumatoid arthritis: a phase II, randomized, double-blind, placebo-controlled, dose-ranging Study. J Rheumatol. (Among 283 patients with active rheumatoid arthritis treated with one of 3 doses of belimumab or placebo for 24 weeks followed by an open label 24 week extension, responses were higher at 24 weeks with belimumab [29% vs 16%] and adverse events, that were more frequent with belimumab, included infusion reactions [13% vs 6%], but ALT elevations were not mentioned).
Askanase AD, Yazdany J, Molta CT. (2014). Post-marketing experiences with belimumab in the treatment of SLE patients. Rheum Dis Clin North Am. (Analysis of 3 postmarketing observational studies of belimumab focusing largely on efficacy; "No new safety signals were noted with regards to infections, malignancies, depression or deaths").
Fredericks CA, Kvam KA, Bear J, Crabtree GS, Josephson SA. (2014). A case of progressive multifocal leukoencephalopathy in a lupus patient treated with belimumab. Lupus. (40 year old woman with SLE developed neurological decline 10 months after starting belimumab infusions [while on mycophenolate mofetil and prednisone as well], with JC viral DNA detected in cerebral spinal fluid, a progressive downhill course and death within 6 months).
Sthoeger Z, Lorber M, Tal Y, Toubi E, Amital H, Kivity S, Langevitz P, et al. (2017). Anti-BLyS treatment of 36 Israeli systemic lupus erythematosus patients. Isr Med Assoc J. (Among 36 adults with SLE treated with belimumab for at least one year, it "was well tolerated without significant adverse events").
Ginzler EM, Wallace DJ, Merrill JT, Furie RA, Stohl W, Chatham WW, Weinstein A, et al., LBSL02/99 Study Group. (2014). Disease control and safety of belimumab plus standard therapy over 7 years in patients with systemic lupus erythematosus. J Rheumatol. (Among 449 patients with SLE treated with belimumab for up to 7 years, adverse events were reported as being stable and decreasing in frequency over time; no mention of ALT elevations, hepatotoxicity or deaths from liver disease).
Henegar CE, Eudy AM, Kharat V, Hill DD, Bennett D, Haight B. (2016). Progressive multifocal leukoencephalopathy in patients with systemic lupus erythematosus: a systematic literature review. Lupus. (Systematic review of the literature identified 35 cases of PML reported in patients with SLE, 3 of whom were on no immunosuppressive medications, but possibly implicated drugs included corticosteroids, cyclophosphamide, mycophenolate, azathioprine and rituximab [n=5], while only one had received belimumab).
Stohl W, Schwarting A, Okada M, Scheinberg M, Doria A, Hammer AE, Kleoudis C, et al. (2017). Efficacy and safety of subcutaneous belimumab in systemic lupus erythematosus: a fifty-two-week randomized, double-blind, placebo-controlled study. Arthritis Rheumatol. (Among 836 patients with SLE treated with intravenous belimumab or placebo for 52 weeks, response rates were higher with belimumab while adverse events were similar; injection site reactions occurred in 6% vs 2%; no mention of ALT elevations or hepatotoxicity).
Furie RA, Wallace DJ, Aranow C, Fettiplace J, Wilson B, Mistry P, Roth DA, et al. (2018). Long-term safety and efficacy of belimumab in patients with systemic lupus erythematosus: a continuation of a seventy-six-week phase III parent study in the United States. Arthritis Rheumatol. (Among 268 patients with SLE enrolled in a long term extension trial of intravenous belimumab for up to 7 years, response rates continued to increase, and mean corticosteroid dosage decreased; while adverse events were mostly mild-to-moderate arthralgias, nausea, headache and infections, there were no deaths that were drug related and no mention of ALT elevations or hepatotoxicity; 10% of patients discontinued therapy because of adverse events).
van Vollenhoven RF, Navarra SV, Levy RA, Thomas M, Heath A, Lustine T, Adamkovic A, et al. (2020). Long-term safety and limited organ damage in patients with systemic lupus erythematosus treated with belimumab: a Phase III study extension. Rheumatology (Oxford). (Among 738 patients with SLE entered into an open-label extension trial after two 1-year randomized controlled trials of intravenous belimumab, adverse events decreased or remained stable over time and no deaths were attributed to drug toxicity; ALT elevations above 5 times ULN occurred in <1% of patients during the first 4 years and in none during the subsequent follow up period; no mention of hepatotoxicity, HBV reactivation or liver related severe adverse events).
Brunner HI, Abud-Mendoza C, Viola DO, Calvo Penades I, Levy D, Anton J, Calderon JE, et al., Paediatric Rheumatology International Trials Organisation (PRINTO) and the Pediatric Rheumatology Collaborative Study Group (PRCSG). (2020). Safety and efficacy of intravenous belimumab in children with systemic lupus erythematosus: results from a randomised, placebo-controlled trial. Ann Rheum Dis. (Among 93 children with SLE treated with belimumab or placebo infusions every 4 weeks for 52 weeks, clinical responses were more frequent with belimumab [53% vs 44%] while adverse event rates were similar [79% vs 83%], although serious adverse event rates were less [17% vs 35%], and one patient on belimumab discontinued therapy because of aminotransferase elevations).
Furie R, Rovin BH, Houssiau F, Malvar A, Teng YKO, Contreras G, Amoura Z, et al. (2020). Two-year, randomized, controlled trial of belimumab in lupus nephritis. N Engl J Med. (Among 448 patients with lupus nephritis treated with intravenous belimumab of placebo for 2 years, a primary renal response was more frequent with belimumab [43% vs 32%], while overall and serious adverse event rates were similar between the two groups including herpes zoster [6% vs 4%], opportunistic infections [13% vs 15%], serious infections [4% vs 3%]; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Belimumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Belimumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Belimumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Belimumab)